# Bisphosphonates

## OVERVIEW

### Introduction

The bisphosphonates are pyrophosphate analogues that become incorporated into bone matrix and suppress osteoclastic activity, thereby reducing bone turnover and increasing bone mass, which makes them valuable agents for the prevention and therapy of osteoporosis. Therapy with the bisphosphonates has been associated with a low rate of serum enzyme elevations during therapy and has been linked to rare instances of clinically apparent liver injury.

### Background

Bisphosphonates are pyrophosphate analogues that have two phosphonate groups attached to a central carbon atom that replaces the oxygen present in pyrophosphate. The bisphosphonates bind calcium and are rapidly taken up in bone matrix where they suppress osteoclastic activity and change the balance between bone resorption and bone formation, thus increasing bone mass. The bisphosphonates have been shown to be effective in treating malignant hypercalcemia and in preventing and treating osteoporosis. Six bisphosphonates have been approved for use in the United States (pronunciation and year of approval given in parentheses) and they differ in formulation, recommended dose regimen, spectrum of activity and clinical indications.

• Alendronate (a len' droe nate) (1995) is available in tablets of 5 and 10 mg for daily use, 35, 40 and 70 mg (with and without vitamin D) for weekly use, and as a suspension for oral use in several generic forms and under the brand name Fosamax. Indications include prevention and treatment of osteoporosis and treatment of Paget disease of bone.

• Etidronate (e" ti droe' nate) (1977) is available in tablets of 200 and 400 mg for daily use in generic forms and under the trade name Didronel. Indications include Paget disease of bone and heterotopic ossification, but it has also been used off label for therapy of osteoporosis.

• Ibandronate (eye" ban droe' nate) (2003) is available in tablets of 2.5 mg for daily and 150 mg for monthly use and as an intravenous formulation under the trade name Boniva. Indications include prevention and treatment of osteoporosis.

• Pamidronate (pam" i droe' nate) (1991) is available as an intravenous formulation generically and under the trade name Aredia. Indications include hypercalcemia of malignancy, multiple myeloma and Paget disease of bone.

• Risedronate (ris" e droe' nate) (1998) is available in tablets of 5 mg for daily use, 30 and 35 mg for weekly use, and 75 and 150 mg for monthly use in generic forms and under the trade name Actonel. Indications include osteoporosis and Paget disease of bone.

• Zoledronic acid (zoe" le droe' nate) (2001) is available as several intravenous formulations generically and under the brand names Zometa and Reclast. Indications and dosage vary by preparation, but include prevention and treatment of osteoporosis, Paget disease of bone, hypercalcemia of malignancy and multiple myeloma.

The side effects of the bisphosphonates vary by route of administration, but are largely class specific. The oral formulations are generally well tolerated, but are recommended to be given on an empty stomach and with care that they enter the stomach (by drinking water and remaining upright) to avoid esophageal irritation and potential ulceration. Common side effects of oral formulations include headache, abdominal discomfort, dyspepsia, nausea and hypocalcemia. The intravenous formulations of the bisphosphonates can be associated with local infusion reactions and in an acute phase reaction in up to 30% of patients. This is characterized by a flu-like syndrome primarily with the initial infusion. Symptoms arise within 10 to 20 hours after the infusion and are accompanied by increases in C reactive protein, decreases in serum zinc and, in some instances, minor elevations in serum enzymes several days later. Severe side effects of the bisphosphanates are rare, but have included esophageal ulcer, gastrointestinal bleeding, atrial fibrillation and, with long-term treatment, osteonecrosis of the jaw and atypical femoral fractures.

### Hepatotoxicity

In most large prospective trials, the bisphosphonates were associated with only rare and isolated instances of serum enzyme elevations and no cases of clinically apparent liver injury. Since their general availability and wide scale use, however, there have been occasional publications reporting clinically apparent acute liver injury due to the more commonly used bisphosphonates (alendronate, ibandronate, risedronate, zoledronate), some of which were accompanied by mild jaundice. The time to onset ranged from 2 to 6 months or more, and patients typically presented with abdominal discomfort and nausea, sometimes followed by jaundice. The pattern of serum enzyme elevations was hepatocellular and liver histology showed an acute toxic hepatitis. Immunoallergic features (fever, rash, eosinophilia) and autoantibodies were uncommon. Most cases were mild-to-moderate in severity and most published cases resolved with drug discontinuation, although full recovery was not always prompt.

In addtion, the bisphosphonates given as intravenous infusions (zoledronate, ibandronate, pamidronate) have been associated with rare instances of mild hypersensitivity reactions with rash and fever which may be accompanied by transient and mild serum enzyme elevations without jaundice typically in association with an acute phase reaction occurring with the initial dose. In some cases, infusions can be tolerated using premedication with glucocorticoids or antihistamines. With repeated doses, these reactions become less severe and may disappear. No instances of acute liver failure or chronic liver disease have been convincingly linked to use of the bisphosphonates.

Likelihood scores:

Alendronate: C (probable rare cause of clinically apparent liver injury).

Etidronate: E* (unproven but suspected rare cause of clinically apparent liver injury).

Ibandronate: D (possible rare cause of clinically apparent liver injury).

Pamidronate: E* (unproven but suspected rare cause of clinically apparent liver injury). Risedronate: D (possible rare cause of clinically apparent liver injury).

Zoledronic acid: C (probable rare cause of clinically apparent liver injury).

### Mechanism of Injury

The bisphosphonates are taken up by bone matrix and rapidly cleared from the serum by renal excretion. Hepatic metabolism is minimal, and thus it is somewhat surprising that they can be associated with hepatic injury. The mechanism of injury is likely to be metabolic idiosyncrasy as immunoallergic features are not typical.

### Outcome and Management

The clinically apparent acute liver injury attributed to bisphosphonates has been mild-to-moderate in severity without published instances of acute liver failure or chronic liver disease. The possibility of cross reactivity of the hepatic injury among the various bisphosphonates has not been studied, nor is there published experience with rechallenge using the same bisphosphonates. Cross reactivity to such injury should be assumed and switching to another agent done with caution and careful monitoring.

References to the safety and potential hepatotoxicity of all six agents are given at the end of this Overview section.

Drug Class: Osteoporosis Agents, Bone Resorption Inhibitors

## CASE REPORTS

### Case 1. Asymptomatic rise in serum aminotransferase levels during alendronate therapy.

[Modified from: de La Serna Higuera C, Pérez Villoria A, Rodríguez Gómez S, Martínez Moreno J, Betancourt González A, Martín Arribas M. [Alendronate-induced hepatocellular lesion]. Gastroenterol Hepatol 2001; 24: 244-6. Spanish. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/11412594)]

A 76 year old woman with osteoporosis was found to have abnormal serum aminotransferase levels on routine testing done 3 months after starting alendronate (10 mg daily). She had no history of liver disease, alcohol abuse or risk factors for viral hepatitis. Her other medical conditions included hypertension, but she was not taking any other medications. She denied symptoms of liver disease and physical examination was normal without rash, fever, or hepatic enlargement or tenderness. Serum ALT levels were elevated with ALT 484 U/L, AST 368 U/L, and GGT 118 U/L, but normal alkaline phosphatase, bilirubin and prothrombin time (Table). Tests for hepatitis A, B and C (including HCV RNA) were negative as were routine autoantibodies. Abdominal ultrasound showed no abnormalities of the liver or biliary tree. Alendronate was continued and she was monitored. Two months later, serum aminotransferase levels had risen further and alendronate was stopped. Liver test abnormalities subsequently improved and serum aminotransferase levels were largely normal six weeks later.

#### Key Points

Medication: | Alendronate (10 mg daily)
Pattern: | Hepatocellular (R=12)
Severity: | 1+ (serum enzyme elevations without jaundice or symptoms)
Latency: | 3 months
Recovery: | 6 weeks
Other medications: | None

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL)
3 months | 0 | 484 | 218 | 1.1
5 months | 0 | 750 | 209 | 1.0
5.5 months | 2 weeks | 316 | 221 | 0.9
8 months | 6 weeks | 38 | 204 | 0.9
10 months | 3 months | 33 | 203 | 0.8
Normal Values | | <40 | <280 | <1.2

#### Comment

The absence of any other cause of liver injury combined with worsening abnormalities while alendronate was continued, followed by prompt improvement on stopping, is reasonably good evidence that the bisphosphonate was the cause of the liver test abnormalities. The patient was never jaundiced and was minimally symptomatic.

### Case 2. Asymptomatic rise in serum aminotransferase levels after initial dose of zoledronic acid.

[Modified from: Jiang Y, Fu Y, Xing XP, Li M, Wang O, Xia WB, Meng XW. Zoledronic acid-induced hepatotoxicity relieved after subsequent infusions in a Chinese woman with glucocorticoid-induced osteoporosis. Eur J Med Res 2015; 20: 68. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/26297149)]

A 50 year old woman with glucocorticoid-induced osteoporosis developed fever, myalgia and arthralgia a few hours after an initial infusion of zoledronic acid and 3 days later was found to have abnormal serum aminotransferase levels which had been normal before treatment (Table). She had no history of liver disease, alcohol abuse or risk factors for viral hepatitis. She had a history of Behcet disease for which she was treated with corticosteroids in varying doses for the previous 12 years. Her other medical conditions included diabetes for which she was taking metformin. Osteoporosis was diagnosed when she developed back pain and vertebral fractors after a fall. She did not improve with modification of her corticosteroid dose, calcitriol and elemental calcium and zoledronic acid was given. Her flu-like symptroms developed a few hours after the initial infusion, but resolved rapidly. Routine blood tests 3 days later showed serum enzyme elevations without jaundice or symptoms. These resolved within the following two weeks. Serum bilirubin and alkaline phosphatase levels remained normal. She received a second influsion of zoledronic acid one year later and again had mild fever and arthralgia as well as minimal ALT elevations 3 days later. A third infusion of zolendronic acid the following year was well tolerated, without fever or myalgia and will no subsequent rise in serum enzymes.

#### Key Points

Medication: | Zoledronic acid (5 mg intravenously once yearly)
Pattern: | Hepatocellular (R=~6.4)
Severity: | 1+ (serum enzyme elevations without jaundice or symptoms)
Latency: | 3 days
Recovery: | ~2 weeks
Other medications: | Metformin, methylprednisolone, glucurolactone, calcitriol

#### Laboratory Values

Time After Administration | ALT (U/L) | Alk P (U/L) | GGT (U/L) | Bilirubin (mg/dL)
Immediately before | 33 | 77 | 45 | 0.6
1st infusion | Zoledronic acid (5 mg iv), followed by fever and arthralgia
3 days | 254 | | 135 | 0.4
6 days | 126 | 118 | 112 | 0.5
9 days | 66 | | | 0.7
1 year | 28 | 44 | 30 | 0.6
2nd infusion | Zolendronic acid (5 mg iv), followed by fever and arthralgia
3 days (after 2nd) | 70 | | 46 | 0.3
6 days (after 2nd) | 48 | 58 | 43 | 0.4
2 years | 24 | 51 | 27 | 0.5
3rd infusion | Zolendronic acid (5 mg iv), followed by no fever or pain
3 days (after 3rd) | 31 | 55 | 33 | 0.4
Normal Values | <40 | <120 | <67 | <1.2

#### Comment

Intravenous formulations of bisphosphanates are associated with an acute phase reaction in approximately one-third of patients. Flu-like symptoms of fever, fatigue, muscle and joint aches, gastrointestinal upset and nausea arise within hours of the infusion, but are generally mild and transient, resolving within 12 to 48 hours. Monitoring of laboratory tests demonstrates rises in acute phase reactants 1-3 days later and this may be accompanied by mild elevations in serum aminotranferase levels, but generally without symptoms or signs of liver disease and little change in alkaline phosphatase or serum bilirubin levels. The syndrome is most prominent with the first infusion and can be ameliorated by use of NSAIDs or, in more severe cases, corticosteroids.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Alendronate – Generic, Fosamax®

Etidronate – Generic, Didronel®

Ibandronate – Generic, Boniva®

Pamidronate – Generic, Aredia®

Risedronate – Generic, Actonel®

Zoledronic Acid – Reclast®, Zometa®

DRUG CLASS

Osteoporosis Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=alendronate)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Alendronate | 121268-17-5 | C4-H13-N-O7-P2.3H2-O.Na | Alendronate Chemical Structure
Etidronate | 2809-21-4 | C2-H8-O7-P2 | Etidronate Chemical Structure
Ibandronate | 114084-78-5 | C9-H23-N-O7-P2 | Ibandronate Chemical Structure
Pamidronate | 40391-99-9 | C3-H11-N-O7-P2 | Pamidronate Chemical Structure
Risedronate | 105462-24-6 | C7-H11-N-O7-P2 | Risedronate Chemical Structure
Zoledronic Acid | 118072-93-8 | C5-H10-N2-O7-P2 | Zoledronic Acid Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 14 June 2018

Zimmerman HJ. Drugs used to treat rheumatic and musculospastic disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 543. (Review of hepatotoxicity published in 1999; bisphosphonates are not discussed).
Friedman PA. Agents affecting mineral ion homeostasis and bone turnover. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1275-1306. (Textbook of pharmacology and therapeutics).
Adami S, Bhalla AK, Dorizzi R, Montesanti F, Rosini S, Salvagno G, Lo Cascio V. The acute-phase response after bisphosphonate administration. Calcif Tissue Int 1987; 41: 326-31. (Among 52 patients with hyperparathyroidism or Paget disease treated with intravenous amino-derived bisphosphonates, a dose dependent acute phase reaction arose 10-20 hours after the initial infusion with fever, lymphopenia, fall in serum zinc levels and rise in C-reactive protein, resolving spontaneously in 3-4 days). 3124942
Nussbaum SR, Warrell RP Jr, Rude R, Glusman J, Bilezikian JP, Stewart AF, Stepanavage M, et al. Dose-response study of alendronate sodium for the treatment of cancer-associated hypercalcemia. J Clin Oncol 1993; 11: 1618-23. (Multicenter randomized trial of 5 dose regimens of intravenous alendronate in 59 patients with malignant hypercalcemia; 8 patients had transient, asymptomatic aminotransferase elevations, which were reversible in all instances). 8336198
Liberman UA, Weiss SR, Bröll J, Minne HW, Quan H, Bell NH, Rodriguez-Portales J, et al. Effect of oral alendronate on bone mineral density and the incidence of fractures in postmenopausal osteoporosis. The Alendronate Phase III Osteoporosis Treatment Study Group. N Engl J Med 1995; 333: 1437-43. (Controlled trial of daily alendronate vs placebo for 2 years in 994 women with osteoporosis; "Alendronate was generally well tolerated, with no greater clinical or laboratory evidence of adverse effects than with placebo"). 7477143
Chesnut CH 3rd, McClung MR, Ensrud KE, Bell NH, Genant HK, Harris ST, Singer FR, et al. Alendronate treatment of the postmenopausal osteoporotic woman: effect of multiple dosages on bone mass and bone remodeling. Am J Med 1995; 99: 144-52. (Controlled trial of multiple doses of daily oral alendronate vs placebo in 188 women with osteopenia; higher doses were associated with gastrointestinal intolerance, rash and "transient, small increases" in ALT [< twice ULN], which resolved spontaneously or with drug discontinuation and no clinically apparent liver injury). 7625419
Conte PF, Latreille J, Mauriac L, Calabresi F, Santos R, Campos D, Bonneterre J, et al. Delay in progression of bone metastases in breast cancer patients treated with intravenous pamidronate: results from a multinational randomized controlled trial. The Aredia Multinational Cooperative Group. J Clin Oncol 1996; 14: 2552-9. (Controlled trial of intravenous pamidronate in 295 women undergoing chemotherapy for breast cancer; during 1598 infusions adverse events included transient elevation in AST [<3 times ULN] in one patient). 8823335
Black DM, Cummings SR, Karpf DB, Cauley JA, Thompson DE, Nevitt MC, Bauer DC, et al. Randomised trial of effect of alendronate on risk of fracture in women with existing vertebral fractures. Fracture Intervention Trial Research Group. Lancet 1996; 348: 1535-41. (Controlled trial of 24 months of daily alendronate vs placebo in 2027 women with previous history of vertebral fracture, "the rates of all adverse events and gastrointestinal adverse events...did not differ by study treatment"). 8950879
Lieverse RJ. Hepatitis after alendronate. Neth J Med 1998; 53: 271-2. (77 year old woman developed weight loss and jaundice 6 months after starting alendronate [bilirubin 16.9 mg/dL, ALT 25 times ULN, Alk P 3 times ULN], resolving within 3 months of stopping). 9883006
Cummings SR, Black DM, Thompson DE, Applegate WB, Barrett-Connor E, Musliner TA, Palermo L, et al. Effect of alendronate on risk of fracture in women with low bone density but without vertebral fractures: results from the Fracture Intervention Trial. JAMA 1998; 280: 2077-82. (Controlled trial of oral alendronate vs placebo in 4432 women with osteopenia for an average of 4.2 years; there was no differences in rates of adverse events between the two groups). 9875874
Dooley M, Balfour JA. Ibandronate. Drugs 1999; 57: 101-8; discussion 109-10. (Review of chemistry, pharmacology, efficacy and safety of ibandronate; "no significant changes were observed in laboratory parameters ... or liver and kidney function in ibandronate recipients"). 9951955
Laitinen K, Taube T. Clodronate as a cause of aminotransferase elevation. Osteoporos Int 1999; 10: 120-2. (Controlled trial of 5 different dose regimens of clodronate or placebo in 610 postmenopausal women with osteopenia, showed dose related average increase in ALT and AST levels, with increase above normal in 18% of clodronate treated vs 7% [1 of 14] of controls). 10501791
Pols HA, Felsenberg D, Hanley DA, Stepán J, Muñoz-Torres M, Wilkin TJ, Qin-sheng G, et al. Multinational, placebo-controlled, randomized trial of the effects of alendronate on bone density and fracture risk in postmenopausal women with low bone mass: results of the FOSIT study. Fosamax International Trial Study Group. Osteoporos Int 1999; 9: 461-8. (Controlled trial of 1 year course of daily oral alendronate vs placebo in 1908 women with osteopenia found no differences in rates of adverse events between the two groups; ALT results not mentioned). 10550467
Peter C, Rodan GA. Preclinical safety profile of alendronate. Int J Clin Pract Suppl 1999; 101: 3-8. (Acute and chronic toxicity studies of alendronate in animals found nephrotoxicity and decreases in calcium and phosphate with very high doses, but no evidence of toxicity at standard human therapeutic doses). 12669734
Watts N, Freedholm D, Daifotis A. The clinical tolerability profile of alendronate. Int J Clin Pract Suppl 1999; 101:51-61. (Overview of side effects of alendronate in large prelicensure, controlled trials in more than 17,000 women; overall, laboratory adverse events were more common with placebo [9.3%] than alendronate [6.3%] and there were no serious laboratory adverse events; hepatotoxicity and ALT elevations were not discussed). 12669741
Orwoll E, Ettinger M, Weiss S, Miller P, Kendler D, Graham J, Adami S, et al. Alendronate for the treatment of osteoporosis in men. N Engl J Med 2000; 343: 604-10. (Controlled trial of daily oral alendronate vs placebo in 241 men with osteoporosis; one man on alendronate stopped therapy because of high AST levels, but details not given). 10979796
Halabe A, Lifschitz BM, Azuri J. Liver damage due to alendronate. N Engl J Med 2000; 343: 365-6. (71 year old woman developed asymptomatic elevations in serum enzymes 2 months after starting alendronate [ALT 163 rising to 447 U/L, Alk P 151 rising to 224 U/L], abnormalities resolving within 4 months of stopping). 10928896
de La Serna Higuera C, Pérez Villoria A, Rodríguez Gómez S, Martínez Moreno J, Betancourt González A, Martín Arribas M. [Alendronate-induced hepatocellular lesion]. Gastroenterol Hepatol 2001; 24: 244-6. Spanish. (76 year old woman developed elevated ALT levels 3 months after starting alendronate [ALT 484 U/L, Alk P normal], resolving within 6 weeks of stopping: Case 1). 11412594
Carrère C, Duval JL, Godard B, De Jaureguiberry JP, Ciribilli JM. [Severe acute hepatitis induced by alendronate]. Gastroenterol Clin Biol 2002; 26: 179-80. French. (71 year old woman developed jaundice 4 months after starting alendronate [bilirubin 21.7 mg/dL, ALT 25 times ULN, Alk P 1.1 times ULN], resolving within 3 months of stopping). 11938071
Greenspan S, Field-Munves E, Tonino R, Smith M, Petruschke R, Wang L, Yates J, et al. Tolerability of once-weekly alendronate in patients with osteoporosis: a randomized, double-blind, placebo-controlled study. Mayo Clin Proc 2002; 77: 1044-52. (Controlled trial of 12 week courses of once weekly alendronate vs placebo in 450 men and women with osteoporosis; there were no differences in rates of side effects between the two groups; no mention of ALT levels). 12374248
Guañabens N, Parés A, Ros I, Alvarez L, Pons F, Caballería L, Monegal A, et al. Alendronate is more effective than etidronate for increasing bone mass in osteopenic patients with primary biliary cirrhosis. Am J Gastroenterol 2003; 98: 2268-74. (32 women with primary biliary cirrhosis were treated with alendronate or etidronate for 14 days every 3 months for up to 2 years; there were no significant changes in liver biochemical test results). 14572578
Eisman JA, Rizzoli R, Roman-Ivorra J, Lipschitz S, Verbruggen N, Gaines KA, Melton ME. Upper gastrointestinal and overall tolerability of alendronate once weekly in patients with osteoporosis: results of a randomized, double-blind, placebo-controlled study. Curr Med Res Opin 2004; 20: 699-705. (Analysis of adverse events in 449 women and men with osteoporosis treated with once weekly alendronate vs placebo for 12 weeks; upper gastrointestinal side effects occurred at similar rates in the two groups [9.8% vs 9.4%], but results of ALT values and other laboratory tests were not mentioned). 15140336
Chesnut III CH, Skag A, Christiansen C, Recker R, Stakkestad JA, Hoiseth A, Felsenberg D, et al.; Oral Ibandronate Osteoporosis Vertebral Fracture Trial in North America and Europe (BONE). Effects of oral ibandronate administered daily or intermittently on fracture risk in postmenopausal osteoporosis. J Bone Miner Res 2004; 19: 1241-9. (Controlled trial of oral ibandronate vs placebo in 2496 women with osteopenia for up to 3 years; there were no differences in frequency of side effects between ibandronate and placebo treated groups and no "clinically relevant changes in laboratory parameters"). 15231010
Phillips MB. Risedronate-induced hepatitis. Am J Med 2007; 120: e1-2. (81 year old woman with osteoporosis developed rise in ALT after 3 years of risedronate therapy, resolving slowing upon stopping; few details given). 17349419
Yanik B, Turkay C, Atalar H. Hepatotoxicity induced by alendronate therapy. Osteoporos Int 2007; 18: 829-31. (47 year old woman developed abdominal pain 2 months after starting alendronate [bilirubin not given, ALT 46 rising to 114 U/L, GGT 30 rising to 84 U/L], resolving within 3 months of stopping). 17226065
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, none were attributed to a bisphosphonate). 18955056
Papapetrou PD. Bisphosphonate-associated adverse events. Hormones (Athens) 2009; 8: 96-110. (Review of side effects of bisphosphonates mentions that a few cases of hepatitis have been reported). 19570737
Polyzos SA, Kountouras J, Anastasilakis AD, Litsas I, Kita M, Arsos G, Moralidis E, Terpos E. Zoledronic acid-induced transient hepatotoxicity in a patient effectively treated for Paget's disease of bone. Osteoporos Int 2011; 22: 363-7. (53 year old woman with Paget disease developed mild flu-like symptoms and serum enzyme elevations within a day of zoledronic acid infusion [bilirubin 0.4 mg/dL ALT rising from 19 to 127 U/L, GGT from 11 to 74 U/L], falling to normal within two weeks). 20407889
Rudic JS, Giljaca V, Krstic MN, Bjelakovic G, Gluud C. Bisphosphonates for osteoporosis in primary biliary cirrhosis. Cochrane Database Syst Rev 2011; 7 (12): CD009144. (Systematic review of studies on safety and efficacy of bisphosphonates in primary biliary cirrhosis found no evidence that they adversely affected the underlying liver disease). 22161446
Anastasilakis AD, Polyzos SA, Makras P, Sakellariou GT, Bisbinas I, Gkiomisi A, Delaroudis S, et al. Acute phase response following intravenous zoledronate in postmenopausal women with low bone mass. Bone 2012; 50: 1130-4. (Among 51 women with osteoporosis given a single intravenous dose of zoledronic acid, 28 [55%] developed an acute phase reaction starting 18 hours after the infusion and lasting for 43 hours with fever, muscle and joint pain, fatigue and headache with decrease in lymphocytes and increase in CRP, IL-1, IL-6 and TNF, but no change in mean ALT, AST or Alk P at 48 hours). 22366634
Kaemmerer D, Schmidt B, Lehmann G, Wolf G, Settmacher U, Hommann M. Treatment of bone loss in patients with chronic liver disease awaiting liver transplantation. Transplant Res 2012; 1: 7. (Among 31 patients with osteoporosis undergoing liver transplantation treated with oral ibandronate, calcium and vitamin D for one year, none had worsening bone mineral density scores, and mean scores increased by 13-24% at the lumbar spine and 3-5% at the femoral neck; no mention of adverse events). 23369371
Goossens N, Spahr L, Rubbia-Brandt L. Severe immune-mediated drug-induced liver injury linked to ibandronate: A case report. J Hepatol 2013 59; 1139-42. (61 year old woman with lupus erythematosus developed fatigue 4 months after starting monthly injections of ibandronate and 12 months after starting atorvastatin [bilirubin 8.0 mg/dL, ALT 1684 U/L, Alk P 208 U/L, ANA 1:640, SMA 1:160, IgG 2,850 mg/dL], responding to prednisone, but relapsing when they were stopped, ultimately resolving after ursodiol therapy). 23770145
Guañabens N, Monegal A, Cerdá D, Muxí A, Gifre L, Peris P, Parés A. A randomized trial comparing monthly ibandronate and weekly alendronate for osteoporosis in patients with primary biliary cirrhosis. Hepatology 2013 58: 2070-8. (Controlled trial comparing two year course of alendronate weekly vs ibandronate monthly in 33 patients with primary biliary cirrhosis, found no worsening of liver tests with either drug during therapy). 23686738
Suresh E, Pazianas M, Abrahamsen B. Safety issues with bisphosphonate therapy for osteoporosis. Rheumatology (Oxford) 2014; 53: 19-31. (Systematic review of the adverse events associated with long term bisphosphonate therapy focusing upon osteonecrosis, atrial fibrillation, cancer and atypical femoral fractures, and mentioning that isolated cases of liver injury have been reported with alendronate [Yanik, 2007] and zolendronate [Polyzos, 2011]). 23838024
Tadrous M, Wong L, Mamdani MM, Juurlink DN, Krahn MD, Lévesque LE, Cadarette SM. Comparative gastrointestinal safety of bisphosphonates in primary osteoporosis: a network meta-analysis. Osteoporos Int 2014; 25: 1225-35. (Systematic review of 50 publications mentioning the gastrointestinal adverse events associated with long term bisphosphonate therapy; does not mention liver toxicity). 24287510
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Among 176 published reports of drug induced liver injury between 1996 and 2012, none were attributed to a drug for osteoporosis). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, only 1 case was attributed to a bisphosphate, a self limited case of acute hepatitis with jaundice that was considered "possibly" due to zoledronic acid). 25754159
Jiang Y, Fu Y, Xing XP, Li M, Wang O, Xia WB, Meng XW. Zoledronic acid-induced hepatotoxicity relieved after subsequent infusions in a Chinese woman with glucocorticoid-induced osteoporosis. Eur J Med Res 2015; 20: 68. (52 year old Chinese woman with corticosteroid induced osteoporosis developed fever after a first infusion of zoldedronate and had transient serum enzyme elevations [biliurbin 0.5 mg/dL, ALT 254 U/L, Alk P 118 U/L], resolving within 1 week and not recurring with subsequent yearly infusions). 26297149
Lu Y, Pei Y, Shao Y, Yan S, Ma L, Fang F, Jin M, et al. Hepatotoxicity induced by zoledronic acid in an aged woman with primary osteoporosis. EXCLI J 2013; 12: 115-7. (73 year old woman developed flu like symptoms and had abnormal serum enzymes 3 days after an initial infusion of zoledronic acid [bilirubin not provided, ALT rising from 17 to 169 U/L, GGT from 41 to 85 U/L], falling into the normal range within 2 weeks). 27034632
Reid IR. Short-term and long-term effects of osteoporosis therapies. Nat Rev Endocrinol 2015; 11: 418-28. (Review of osteoporosis, its management and treatment, mentions that intravenous bisphonosphates produce an acute phase response in one-third of patients). 25963272
Mukaiyama K, Kamimura M, Uchiyama S, Ikegami S, Nakamura Y, Kato H. Elevation of serum alkaline phosphatase (ALP) level in postmenopausal women is caused by high bone turnover. Aging Clin Exp Res 2015; 27: 413-8. (Among 626 postmenopausal women with osteoporosis, serum Alk P levels were elevated in 14%, largely due to bone rather than hepatic sources; treatment with alendronate and risedronate led to decreases in levels into the normal range in 65 of 84 subjects). 25534961
Rossini M, Adami G, Adami S, Viapiana O, Gatti D. Safety issues and adverse reactions with osteoporosis management. Expert Opin Drug Saf 2016; 15: 321-32. (Review of the safety of drugs for osteoporosis mentions that intravenous nitrogen-containing bisphosphonates cause an acute phase response in about 30% of patients, marked by transient flu-like symptoms within a day of administration that resolves within 3 days and decreases in severity with subsequent infusions). 26699669
Schneider JS, Montani M, Stickel F. Drug-Induced Autoimmune Hepatitis following Treatment with Zoledronic Acid. Case Rep Gastroenterol 2017; 11: 440-5. (73 year old woman developed fever, fatigue and pruritus and elevations in serum enzymes shortly after an initial infusion of zoledronic acid for osteoporosis [bilirubin not provided, ALT 183 U/L, GGT 639 U/L], ultimately treated with prednisone after enzymes remained elevated for 4 weeks, with an initial response and relapse when withdrawn 10 weeks later requiring reinitiation of immunosuppressive therapy). 29033761

## OTHER REFERENCE LINKS

1. Recent References on Bisphosphonates: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Bisphosphonates)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%222009/11/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Bisphosphonates: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Bisphosphonates)